# Luspatercept

## OVERVIEW

### Introduction

Luspatercept is a recombinant fusion protein that combines the extracellular domain of the human activin receptor with the Fc fragment of immunoglobulin G and acts by interfering with transforming growth factor beta signaling and is used to treat severe forms of anemia due to beta thalassemia or myelodysplastic syndromes. Luspatercept has been linked to a low rate of serum enzyme elevations during therapy, but has not been linked to cases of clinically apparent liver injury with jaundice.

### Background

Luspatercept (lus pat’ er sept) is a recombinant fusion protein that combines the extracellular domain of human activin receptor type IIB with the Fc fragment of immunoglobulin G. Luspatercept stimulates the production of erythrocytes via inhibition of ligands, which activate intracellular pathways (by reducing SMAD2, SMAD3 signaling) that mediate intracellular apoptosis of erythrocytes. Inhibition of this pathway causes an increase in erythrocyte maturation and proliferation. In clinical trials in patients with refractory and severe anemia due to beta thalassemia, myelofibrosis and myelodysplastic syndromes, luspatercept therapy decreased transfusion requirements and increased hemoglobulin levels in 60% to 70% of patients. Luspatercept was approved as therapy of beta thalassemia in the United States in 2019, and a year later its indications were expanded to include patients with myelodysplastic syndromes who were transfusion dependent or not responding to growth factor therapy. Luspatercept is available under the brand name Reblozyl as a lyophilized power for subcutaneous administration in single use vials of 25 and 75 mg. Luspatercept is given subcutaneously every 3 weeks in doses based upon body weight, the initial dosage being 1.0 mg/kg with potential for dose increase (1.25, 1.33 or 1.75 mg/kg) or decrease (to 0.8 or 0.6 mg/kg) depending upon efficacy and tolerance. Common side effects include injection site reactions, hypertension and nonspecific symptoms of fatigue, headache, dizziness, body pain and rash. Acute hypersensitivity reactions occur in <1% of patients. Less common, but potentially severe side effects include an increased risk of thrombosis and thromboembolism, severe hypertension, and embryo-fetal toxicity.

### Hepatotoxicity

In prelicensure controlled trials, serum ALT elevations occurred in 9% to 12% with luspatercept and a similar proportion of subjects treated with placebo (7% to 12%). The elevations were usually mild-to-moderate in severity, asymptomatic and self-limited in course. ALT elevations above 5 times the ULN occurred in 1% to 2% of recipients and rarely led to discontinuation of therapy. Luspatercept therapy was also associated with serum bilirubin elevations (11% vs 5% in placebo recipients), which occurred in some patients with concurrent serum aminotransferase elevations. However, no patient developed clinically apparent, symptomatic acute liver injury, and some of the bilirubin elevations were likely due to red blood cell hemolysis and enhanced production and turnover, particularly in patients with thalassemia. In preregistration clinical trials and subsequently with its more widespread use, luspatercept has not been linked to instances of clinically apparent liver injury.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

Luspatercept is a recombinant human protein and as such is unlikely to be intrinsically hepatotoxic. Blocking essential intracellular pathways of TGFβ ligands in the liver may lead to some degree of hepatic dysfunction and injury. Hypersensitivity reactions can occur with administration of luspatercept, which may be associated with mild liver enzyme elevations.

### Outcome and Management

Luspatercept has been linked to mild-to-moderate serum enzyme elevations during therapy. Discontinuation for serum enzyme elevations is rarely necessary, but should be done if the elevations are accompanied by symptoms or jaundice or for persistent ALT elevations of more than 5 times the upper limit of normal (ULN). There is no information on cross sensitivity to liver injury between luspatercept and other growth factors or therapies for anemia.

Drug Class: Hematologic Agents

Other drugs for myelodysplastic syndromes: Azacitidine, Decitabine, Decitabine/Cedazuridine

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Luspatercept – Reblozyl®

DRUG CLASS

Hematologic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Luspatercept)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Luspatercept | 1373715-00-4 (https://pubchem.ncbi.nlm.nih.gov/substance/381127153) | Recombinant Protein | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 27 July 2023

Abbreviations used: MDS, myelodysplastic syndrome; sc, subcutaneously; TGFβ, transforming growth factor beta.

FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2020/761136Orig2s000MedR.pdf (FDA website including product label and multidiscipline review of data submitted in support of luspatercept approval includes discussion of hepatotoxicity, therapy being associated with increase in ALT elevations [9% vs 4% with placebo] and bilirubin [11% vs 3%], with several patients having concurrent elevations in both).
Platzbecker U, Germing U, Götze KS, Kiewe P, Mayer K, Chromik J, Radsak M, et al. Luspatercept for the treatment of anaemia in patients with lower-risk myelodysplastic syndromes (PACE-MDS): a multicentre, open-label phase 2 dose-finding study with long-term extension study. Lancet Oncol. 2017;18(10):1338-1347. (Among 58 adults with myelodysplastic syndromes [MDS] treated with varying doses of luspatercept, doses of 0.75-1.75 mg/kg were associated with better responses in hemoglobin levels but also increases in adverse events of fatigue, bone pain and diarrhea; no mention of ALT elevations or hepatotoxicity). 28870615
Fenaux P, Kiladjian JJ, Platzbecker U. Luspatercept for the treatment of anemia in myelodysplastic syndromes and primary myelofibrosis. Blood. 2019;133:790-794. (Review of the mechanism of action and rationale for use of luspatercept and other activin inhibitors in MDS where it blocks TGFβ signaling, which normally inhibits terminal erythroid differentiation; no mention of hepatotoxicity or effect on aminotransferase levels). 30602619
Markham A. Luspatercept: first approval. Drugs. 2020;80:85-90. (Review of the mechanism of action, history of development, pharmacokinetics, clinical efficacy and safety of luspatercept shortly after its approval for use in beta thalassemia mentions side effects of bone pain [20% vs 8% in placebo controls], arthralgia [19% vs 12%], headaches [26% vs 24%], dizziness [11% vs 5%], nausea [9% vs 6%], and hypertension [8% vs 3%], with serious adverse events in 3.6% including cerebral vascular accidents and deep vein thrombosis; no mention of ALT elevations or hepatotoxicity). 31939073
Fenaux P, Platzbecker U, Mufti GJ, Garcia-Manero G, Buckstein R, Santini V, Díez-Campelo M, et al. Luspatercept in patients with lower-risk myelodysplastic syndromes. N Engl J Med. 2020;382:140-151. (Among 229 adults with MDS on transfusion therapy who were treated with luspatercept [1.0 to 1.75 mg/kg] vs placebo injections every 3 weeks for 48 weeks, transfusion independence for at least 8 weeks between weeks 1-24 was achieved by 38% vs 13%, while common adverse events included fatigue [27% vs 13%] diarrhea [22% vs 9%], asthenia [20% vs 12%], nausea [20% vs 9%], dizziness [20% vs 5%] and ALT elevations [5.9% vs 3.9%], which were above 5 times the ULN in 2% vs none, one leading to drug discontinuation). 31914241
Cappellini MD, Viprakasit V, Taher AT, Georgiev P, Kuo KHM, Coates T, Voskaridou E, et al.; BELIEVE Investigators. A phase 3 trial of luspatercept in patients with transfusion-dependent β-thalassemia. N Engl J Med. 2020;382:1219-1231. (Among 336 adults with transfusion dependent beta thalassemia treated with luspatercept [1.0-1.25 mg/kg] or placebo injections every 3 weeks, transfusion burdens decreased by one-third in 21% of luspatercept- vs 4.5% of placebo-treated subjects, while adverse events included bone pain [20% vs 8%], arthralgia [19% vs 12%], dizziness [11% vs 5%], hypertension [8.1% vs 2.8%], uric acid elevations [7.2% vs none], and thromboembolic events [3.6% vs 0.9%]; no mention of ALT elevations or hepatotoxicity). 32212518
Taher AT, Musallam KM, Cappellini MD. β-Thalassemias. N Engl J Med. 2021;384:727-743. (Review of the pathogenesis, clinical features, complications, management and therapy of beta thalassemia including the role of luspatercept, mentions the hepatic complications of transfusion therapy but not hepatotoxicity of luspatercept or other medical treatments). 33626255
Delgado J, Voltz C, Stain M, Balkowiec-Iskra E, Mueller B, Wernsperger J, Malinowska I, et al. The European Medicines Agency review of luspatercept for the treatment of adult patients with transfusion-dependent anemia caused by low-risk myelodysplastic syndromes with ring sideroblasts or beta-thalassemia. Hemasphere. 2021;5:e616. (Summary of the review of luspatercept efficacy and safety supporting the European Medicines Agency’s approval of luspatercept for beta-thalassemia and MDS, mentions that total adverse event rates were similar among the 571 patients on luspatercept and the 193 on placebo [95% vs 91%], but that serious adverse events were more frequent [24% vs 15%] with luspatercept as were discontinuations [8.8% vs 3.6%]; no mention of ALT elevations or hepatotoxicity). 34291195
Santini V. Advances in myelodysplastic syndrome. Curr Opin Oncol. 2021;33:681-686. (Review of the pathogenesis, clinical features, complications, diagnosis, cytogenetics, and therapy of MDS mentions the use of luspatercept as well as telomerase inhibitors and hypomethylating agents). 34474438
Schulz F, Nachtkamp K, Kasprzak A, Gattermann N, Haas R, Germing U. Luspatercept as a therapy for myelodysplastic syndromes with ring sideroblasts. Expert Rev Hematol. 2021;14:509-516. (Review of the mechanism of action, clinical efficacy, side effects, and role of luspatercept in management of myelodysplastic syndromes with ring sideroblasts; does not discuss ALT elevations or hepatotoxicity). 34161752
Piga A, Longo F, Gamberini MR, Voskaridou E, Ricchi P, Caruso V, Pietrangelo A, et al. Long-term safety and erythroid response with luspatercept treatment in patients with β-thalassemia. Ther Adv Hematol. 2022;13:20406207221134404. (Among 63 patients with beta thalassemia treated in a long term, open-label extension study of luspatercept [0.6-1.25 mg/kg sc every 3 weeks], increases in hemoglobin were sustained as were reductions in transfusion requirements, while safety was “acceptable”, 88% had an adverse event, 12.5% a severe adverse event, most commonly bone pain [42%], headache [31%], myalgia [22%], 1 case of biliary colic and 1 death [cardiac arrest], no mention of ALT elevations or hepatotoxicity). 36505885
Taher AT, Cappellini MD, Kattamis A, Voskaridou E, Perrotta S, Piga AG, Filosa A, et al.; BEYOND Investigators. Luspatercept for the treatment of anaemia in non-transfusion-dependent β-thalassaemia (BEYOND): a phase 2, randomised, double-blind, multicentre, placebo-controlled trial. Lancet Haematol. 2022;9:e733-e744. (Among 145 patients with non-transfusion dependent beta-thalassemia treated with luspatercept [1.0 to 1.25 mg/kg sc every 3 weeks] vs placebo for at least one year, hemoglobin levels rose by 1.0 mg/dL or greater in a greater proportion of luspatercept vs placebo recipients [77% vs none], while serious adverse events were less frequent [11% vs 25%]; common adverse events of luspatercept include bone pain [37% vs 6%], headache [30% vs 20%] and arthralgia [29% vs 14%], while changes in ALT levels and hepatotoxicity were not mentioned ). 36007538
Sekeres MA, Taylor J. Diagnosis and treatment of myelodysplastic syndromes: a review. JAMA. 2022;328:872-880. (Concise review of clinical features, natural history, diagnosis, and management of MDS; adverse events are listed in tables but without mention or discussion of ALT elevations or hepatotoxicity). 36066514
Platzbecker U, Götze KS, Kiewe P, Germing U, Mayer K, Radsak M, Wolff T, et al. Long-term efficacy and safety of luspatercept for anemia treatment in patients with lower-risk myelodysplastic syndromes: the phase II PACE-MDS Study. J Clin Oncol. 2022;40:3800-3807. (Among 108 patients with lower-risk MDS treated with luspatercept for up to 5 years [median=1 year], 54% had a hematologic improvement while adverse events arose in 45% including fatigue, hypertension, diarrhea, headache and bone pain; no mention of ALT elevations or hepatotoxicity). 35998303
Platzbecker U, Della Porta MG, Santini V, Zeidan AM, Komrokji RS, Shortt J, Valcarcel D, et al. Efficacy and safety of luspatercept versus epoetin alfa in erythropoiesis-stimulating agent-naive, transfusion-dependent, lower-risk myelodysplastic syndromes (COMMANDS): interim analysis of a phase 3, open-label, randomised controlled trial. Lancet. 2023;402:373-385. (Among 356 adults with low or intermediate risk MDS with transfusion dependence treated with either luspatercept [1-1.75 mg/kg] sc every 3 weeks or epoetin [450-1050 IU/kg] sc every week for at least 24 weeks, transfusion independence was achieved in 59% vs 31% and adverse events were frequent [92% vs 85%], often serious [38% vs 35%] and for luspatercept included fatigue, weakness, nausea, dyspnea, hypertension and headache; liver toxicity arose in 2% vs 3% but only one [on epoetin] was serious). 37311468
Lanino L, Restuccia F, Perego A, Ubezio M, Fattizzo B, Riva M, Consagra A, et al; Fondazione Italiana Sindromi Mielodisplastiche (FISiM) Clinical network. Real-world efficacy and safety of luspatercept and predictive factors of response in patients with lower risk myelodysplastic syndromes with ring sideroblasts. Am J Hematol. 2023;98:E204-E208. (Among 201 adults with low or intermediate risk MDS with ring sideroblasts and transfusion dependence treated in an Italian observational, compassionate use protocol of luspatercept [1.0-1.75 mg/kg] for up to one year, transfusion independence was achieved in 39% of patients, while serious adverse events arose in 17% which were largely cardiac, infectious, and accidents; no mention of ALT elevations or hepatotoxicity). 37222267
Garcia-Manero G. Myelodysplastic syndromes: 2023 update on diagnosis, risk-stratification, and management. Am J Hematol. 2023;98:1307-1325. (Review of the classification of MDS and risk categorization with an update on management including discussion of hypomethylation agents and luspatercept; no mention of ALT elevations or hepatotoxicity). 37288607
Randall MP, DeZern AE. The management of low-risk myelodysplastic syndromes-current standards and recent advances. Cancer J. 2023;29:152-159. (Review of treatment of low-risk MDS including erythropoietin, iron chelation, lenalidomide, luspatercept and low dose hypomethylating agents; no discussion of hepatotoxicity). 37195771

## OTHER REFERENCE LINKS

Recent References on Luspatercept: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Luspatercept+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Luspatercept: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Luspatercept)